# Antithrombotic Agents

## OVERVIEW

Antithrombotic agents are separated into those drugs that decrease the synthesis of coagulation factors or interrupt the coagulation cascade (anticoagulants) and those that inhibit platelet function (antiplatelet agents). A third class of agents are the thrombolytic drugs which act to promote dissolution of thromboses after they have formed. The antithrombotic agents are rare causes of clinically apparent acute liver injury.

Anticoagulants are used largely for the prevention and treatment of venous thromboses, although they have some activity against arterial thromboses. Their major clinical use is prevention and treatment of deep vein thrombosis in high risk persons (such as after hip or knee replacement surgery or with prolonged immobilization), prevention and treatment of pulmonary embolism, and prevention of arterial embolism in patients with atrial fibrillation.

The anticoagulant agents in clinical use and their year of approval include heparin and its low molecular weight derivatives dalteparin (Fragmin: 1994), enoxaparin (Lovenox: 1993), and tinzaparin (Innohep: 2000); direct thrombin inhibitors such as dabigatran (Pradaxa: 2010) and desirudin (Iprivask: 2003); factor Xa inhibitors such as fondaparinux (Arixtra: 2001), rivaroxaban (Xarelto: 2011), apixaban (Eliquis: 2012) and edoxaban (Savaysa: 2015); and warfarin (Coumadin: 1967), a vitamin K antagonist. Each of the following anticoagulants is discussed individually with accompanying references.

- Dabigatran, Desirudin
- Apixaban, Betrixaban, Edoxaban, Fondaparinux, Rivaroxaban
- Heparins, Heparin, Dalteparin, Enoxaparin, Tinzaparin
- Warfarin

Antiplatelet agents are effective for the prevention and treatment of arterial thromboses (which are platelet rich). Aspirin is an irreversible inhibitor of cyclooxygenase 1, which blocks platelet activation and aggregation for the life of the platelet. Aspirin is commonly used for treatment and prevention of coronary, cerebrovascular and other arterial thromboses (myocardial infarction, stroke, peripheral vascular disease). Dipyridamole increases cyclic adenosine monophosphate (cAMP) levels in platelets by blocking adenosine uptake or inhibiting phosphodiesterases which metabolize cAMP. The increased cAMP levels result in inhibition of platelet aggregation. Dipyridamole is used with or without aspirin for secondary prevention of myocardial infarction or stroke. The thienopyridines, ticlopidine, clopidogrel and prasugrel, inhibit the major adenosine diphosphate receptor (also known as the purinergic receptor, P2Y-12) on platelets which blocks their activation and aggregation. These agents are used for secondary prevention of coronary and cerebrovascular thrombosis. Ticagrelor is a non-thienopyridine platelet aggregation inhibitor with activity similar to the thienopyridines. Ticagrelor is used with aspirin (<100 mg daily) as secondary prevention of arterial thrombosis with acute coronary syndrome. Cangrelor is a platelet aggregation inhibitor similar to ticagrelor which is administered intravenously and has a rapid onset of action and rapid half-life, making it an appropriate as therapy of acute cardiovascular events. Vorapaxar is a inhibitor of the protease-activated receptor 1 (PAR-1) found on platelets that inhibits platelet aggregation and is used to reduct the risk of atherosclerotic events in high risk patients. Finally, the glycoprotein IIb/IIIa receptor blockers have an immediate effect in preventing platelet aggregation, blocking the action of fibrinogen and von Willebrand factor on these platelet receptors; these agents are administered intravenously and are used to attain immediate platelet inhibition in acute coronary syndrome or percutaneous coronary artery intervention. Because of their restricted use, the glycoprotein IIb/IIIa receptor inhibitors are not discussed individually in LiverTox. They have not been convincingly linked to instances of clinically apparent acute liver injury.

The antiplatelet drugs in current use and their year of approval include aspirin; dipyridamole (Persantine: 1961); the thienopyridine inhibitors of P2Y-12 including ticlopidine (Ticid: 1991), clopidogrel (Plavix: 1997), and prasugrel (Effient: 2009); the non-thienopyridine P2Y-12 inhibitors ticagrelor (Brilinta: 2011) and cangrelor (Kenreal: 2015); an inhibitor of PAR-1 vorapaxar (Zontivity: 2014); and the intravenously administered glycoprotein IIb/IIIa receptor blockers including abciximab (ReoPro: 1994) and eptifibatide (Integrilin: 1998). Each of the following antiplatelet agents is discussed individually with accompanying references.

- Aspirin
- Cangrelor
- Clopidogrel
- Dipyridamole
- Prasugrel
- Ticagrelor
- Ticlopidine
- Vorapaxar

Thrombolytic drugs include tissue plasminogen activators (tPA: alteplase, reteplase and tenecteplase), anistreplase, streptokinase and urokinase. These agents are administered intravenously immediately or soon after after arterial or venous thromboses or emboli. These agents have not been definitely linked to instances of acute liver injury. Because of their highly restricted use, they are not discussed in LiverTox.

Other antithrombotic agents include defibrotide, which is a complex mixture of single stranded polydeoxyribonucleotides derived from porcine intestinal mucosa that has antithrombotic and profibrinolytic activity and is used in the treatment of severe sinusoidal obstruction syndrome after hematopoietic cell transplantation. Finally, anagrelide is an antithrombotic agent that inhibits the production of platelets, thereby reducing platelet counts, which is used to treat essential thrombocytosis and other causes of thombocythemia associated with an increased rate of arterial or venous thromboses.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2020

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 528. (Review of hepatotoxicity of anticoagulant and antiplatelet drugs published in 2013).
Hogg K, Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 849-76. (Textbook of pharmacology and therapeutics).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, two were attributed to antithrombotic agents, one to prasugrel and one to dalteparin; none were due to ticagrelor).